# Retinoids

## OVERVIEW

Retinoids are both natural and synthetic derivatives of vitamin A, several of which have been developed for medical uses, largely to replace vitamin A which in high, therapeutic doses is associated with considerable toxicity. Retinoids have multiple actions and play important roles in regulation of cell proliferation and differentiation, vision, bone growth, tumor suppression and immunity. The effects of retinoids are thought to be mediated by their binding to and activation of the retinoic acid and retinoid X receptors which regulate gene expression, important in normal growth and differentiation. Vitamin A in doses that have medical effects was found to be toxic, particularly when given long term. Modification of the vitamin A structure led to retinoid molecules that had many of its beneficial, but fewer of its adverse effects.

Oral retinoids in use in the United States include acitretin for psoriasis and isotretinoin for severe nodular acne. Tretinoin is used topically and several other retinoids have been developed for therapy of uncommon forms of cancer (alitretinoin, bexarotene). The commonly used retinoids have many of the side effects of vitamin A including dry skin, cheilosis and nosebleeds and hair loss, but are not stored in the liver and do not cause the typical form of chronic liver disease associated with excessive vitamin A intake. Both acitretin and isotretinoin are teratogenic and embryotoxic and are contraindicated in women who are or intend to become pregnant. Retinoids have been implicated in causing mild-to-moderate elevations in routine liver tests, but these elevations are usually asymptomatic and transient, resolving spontaneously even with continued therapy. Marked elevations in serum aminotransferase levels during retinoid therapy are uncommon, and dose adjustment or drug discontinuation are rarely required for liver test abnormalities. Nevertheless, laboratory monitoring is recommended with routine liver tests at baseline and one month later, and testing thereafter only if abnormalities were found or symptoms arise. Several retinoids (acitretin, etretinate, retinal acetate) have been associated with a clinically apparent acute liver injury which typically arises during the first 3 months of therapy, has many features of hypersensitivity and can be severe and even fatal. Interestingly, isotretinoin often causes mild serum aminotransferase elevations and is commonly listed as having frequent adverse effects on the liver, but it has not been convincingly linked to instances of severe clinically apparent, acute liver injury with jaundice.

Two retinoids used in dermatology, acitretin and isotretinoin, are discussed in separate chapters; etretinate is discussed with acitretin which has replaced it in clinical practice. General references are provided below. References to the discussed retinoids are given in the annotate bibliographies of the individual chapters

Drug Class: Dermatologic Agents; Vitamins

Other Drugs in the Subclass:

- Vitamin A
- Retinoids
  - Acitretin, Etretinate
  - Isotretinoin
  - Bexarotene

## ANNOTATED BIBLIOGRAPHY

References updated: 10 November 2020

Zimmerman HJ. Vitamin A (retinol). Drugs used in dermatotherapy. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 727-9. (Expert review of hepatotoxicity of vitamin A and the retinoids published in 1999; mentions two published reports of acute necrosis due to acitretin).
Liu LU, Schiano TD. Vitamin A (retinol). Hepatotoxicity of herbal medications, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 744-6. (Review of vitamin A and retinoid hepatotoxicity published in 2007).
Sewell MJ, Burkhart C, Morrell D. Dermatological pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1271-96. (Textbook of pharmacology and therapeutics).
Peck GL, Olsen TG, Yoder FW, Strauss JS, Downing DT, Pandya M, Butkus D, et al. (1979). Prolonged remissions of cystic and conglobate acne with 13-cis-retinoic acid. N Engl J Med. (Initial report on use of isotretinoin for severe acne mentions that mild and transient ALT elevations occurred in one of the 14 patients treated for 4 months).
Thune P, Mork NJ. (1980). A case of centrolobular toxic necrosis of the liver due to aromatic retinoid--Tigason (Ro-10-9359). Dermatologica. (54 year old woman with ichthyosis developed fatigue 2-3 months after starting etretinate [peak bilirubin 2.6 mg/dL, ALT 1260 U/L, Alk P 350 U/L], biopsy showing centrolobular necrosis, with slow resolution over the next 6 months).
Peck GL, Olsen TG, Butkus D, Pandya M, Arnaud-Battandier J, Gross EG, Windhorst DB, et al. (1982). Isotretinoin versus placebo in the treatment of cystic acne. A randomized double-blind study. J Am Acad Dermatol. (Controlled trial of 4 months of isotretinoin in 33 patients with severe acne showed dramatic therapeutic effect; side effects were dry skin, eyes and nasal membranes and dermatitis; ALT elevations occurred in 3 patients [10%], but levels returned to normal despite continuing and no patient stopped therapy because of side effects).
Olson JA. (1983). Adverse effects of large doses of vitamin A and retinoids. Semin Oncol. (Review of retinoids and vitamin A which do not share same toxicity, but usually have a low therapeutic-toxic index).
Ward A, Brogden RN, Heel RC, Speight TM, Avery GS. (1984). Isotretinoin. A review of its pharmacological properties and therapeutic efficacy in acne and other skin disorders. Drugs. (Review of pharmacology, efficacy and safety of isotretinoin: elevations in liver tests occur in 10% of patients, "although these changes rarely reach statistical or clinical significant levels").
Strauss JS, Rapini RP, Shalita AR, Konecky E, Pochi PE, Comite H, Exner JH. (1984). Isotretinoin therapy for acne: results of a multicenter dose-response study. J Am Acad Dermatol. (150 patients with nodulocystic acne were treated with one of 3 doses of isotretinoin [0.1, 0.5 or 1.0 mg/kg/day] for 20 weeks; side effects were common [dry skin, nosebleeds, hair loss, headache], mean ALT and AST values increased slightly in the highest dose group, and AST increases occurred in 15-18% of patients, but did not lead to dose modification or clinical symptoms).
Heller EH, Shiffman NJ. (1985). Synthetic retinoids in dermatology. Can Med Assoc J. (Discussion of two synthetic analogues of vitamin A introduced into dermatology: isotretinoin [used in acne] and etretinate [used in psoriasis]; these retinoids are less toxic than vitamin A and not stored in the liver, although they are metabolized there; minor liver test abnormalities may arise during therapy, but rarely required dose modification).
Vahlquist A. (1985). LöL, Nordlinder H, Rollman O, Vahlquist C. Differential hepatotoxicity of two oral retinoids (etretinate and isotretinoin) in a patient with palmoplantar psoriasis. Acta Derm Venereol. (64 year old woman was found to have abnormal liver tests 5 months after starting etretinate [bilirubin 0.7 mg/dL, ALT 950 U/L, Alk P 402 U/L], liver biopsy showing hepatitis without steatosis, resolving with stopping and prednisone therapy, recurring upon rechallenge, but not when isotretinoin was started which was less effective for the psoriasis).
Yob EH, Pochi PE. (1987). Side effects and long-term toxicity of synthetic retinoids. Arch Dermatol. (Retinoids are modifications of vitamin A molecule and are not stored in the liver; hepatotoxicity of retinoids is different from that of vitamin A, usually arising within first 1-2 months and having features of hypersensitivity).
Larrey D, Fréaux E, Babany G, Berson A, Amée-Manesme O, Degott C, Bettan L, et al. (1988). Gastroenterol Clin Biol. (Seven cases of liver injury in women taking Plethoryl [a retinoid containing combination used to treat obesity], arising after 3-16 weeks of therapy [bilirubin 3.3-26.3 mg/dL, ALT 21-61 times ULN, Alk P 0.9-1.8 times ULN], resolving within 2-3 months of stopping).
David M, Hodak E, Lowe NJ. (1988). Adverse effects of retinoids. Med Toxicol Adverse Drug Exp. (Review of pharmacology, clinical effectiveness and low dose, long term toxicities of the retinoids; states that therapy usually has little effect on ALT or bilirubin levels).
Roenigk HH. (1988). Liver toxicity of retinoid therapy. J Am Acad Dermatol. (Review of hepatotoxicity of vitamin A and the retinoids).
Kragballe K, Jansen CT, Geiger JM, Bjerke JR, Falk ES, Gip L, Hjorth N, et al. (1989). A double-blind comparison of acitretin and etretinate in the treatment of severe psoriasis. Results of a Nordic multicentre study. Acta Derm Venereol. (Controlled trial of acitretin [n=127] vs etretinate [n=41] in psoriasis found similar efficacy; AST elevations occurred in 12% vs 11% and one patient on acitretin for 12 weeks developed biopsy proven "toxic hepatitis" which resolved on stopping).
Fallon MB, Boyer JL. (1990). Hepatic toxicity of vitamin A and synthetic retinoids. J Gastroenterol Hepatol. (Review of liver injury due to hypervitaminosis A and retinoids identified 18 reports of vitamin A hepatotoxicity in the English literature, patient ages 6 to 63 years, presenting with rash, fatigue, hepatomegaly and hepatic synthetic dysfunction, biopsy showing fat in stellate cells and fibrosis; little evidence that isotretinoin causes liver injury other than mild rapidly reversible ALT elevations; etretinate causes ALT elevations in ~20% of patients and case reports of clinically apparent injury have been published, but vary in clinical patterns).
Vahlquist A. (1992). Long-term safety of retinoid therapy. J Am Acad Dermatol. (Patients have been treated with retinoids for up to 15 years, generally without toxicity; retinoids do not accumulate in the liver and do not cause accumulation of fat droplets in stellate cells as occurs with hypervitaminosis A; two types of hepatotoxicity, one idiosyncratic acute hepatitis typically occurring with aromatic retinoids and one a long term low grade injury that can lead to cirrhosis, perhaps aggravated by alcohol that the author claims can occur with all retinoids).
Pilkington T, Brodgen RN. (1992). Acitretin: a review of its pharmacology and therapeutic use. Drugs. (Extensive review of the pharmacology, clinical efficacy, and toxicity of acitretin; vitamin A like side effects are common such as dry skin, lips, eyes and nose, skin desquamation, alopecia, fatigue and pruritus; ALT elevations occur in 16%, but are usually asymptomatic, although cases requiring drug withdrawal have been reported).
Barth JH, Macdonald-Hull SP, Mark J, Jones RG, Cunliffe WJ. (1993). Isotretinoin therapy for acne vulgaris: a re-evaluation of the need for measurements of plasma lipids and liver function tests. Br J Dermatol. (Retrospective analysis of 209 patients treated with isotretinoin found "no significant change in any of the tests of liver function", which led the authors to argue against the recommendation for routine monitoring of liver tests during therapy).
Coschieri M, Philippon A, Quinsat D, Dor JF, Chichmanian RM. (1993). Acute hepatitis involvement during ingestion of acitretin. Gastroenterol Clin Biol. (80 year old man developed nausea and rash one week after starting acitretin [bilirubin normal, ALT 21 times ULN, Alk P normal], resolving within a month of stopping).
Shibata K, Shimamoto Y, Ishibashi S, Tominaga H, Suga K, Yamaguchi M. (1994). Life-threatening hepatic toxicity caused by all-trans-retinoic acid in a patient with acute promyelocytic leukaemia. Clin Lab Haematol. (39 year old man with acute promyelocytic leukemia developed jaundice one month after starting all-trans-retinoic acid with peak bilirubin ~10 mg/dL, resolving in 18 days after stopping and patient achieving remission despite early discontinuation).
Katz HI, Waalen J, Leach EE. (1999). Acitretin in psoriasis: an overview of adverse effects. J Am Acad Dermatol. (Review of side effects of acitretin based upon data from 1877 patients reported "overt chemical hepatitis" in 0.26%; among 128 patients undergoing routine pre- and post-treatment liver biopsies, 83% were improved or unchanged; authors recommend routine monitoring of liver tests every 1-2 weeks "until stable, and thereafter at intervals as clinically indicated").
Perea G, Salar A, Alté A, Brunet S, Sierra J. (2000). Acute hepatomegaly with severe liver toxicity due to all-trans-retinoic acid. Haematologica. (40 year old man with promyelocytic leukemia developed jaundice 21 days after starting all-trans-retinoic acid and idarubicin [direct bilirubin 2.3 mg/dL, ALT normal, Alk P 370 U/L], biopsy showing intrahepatic cholestasis and resolving within 2 weeks of stopping).
Mawson AR, Steele TA. (2001). Possible role of retinoids in hepatitis B virus-associated liver damage. Exp Biol Med (Maywood). (Review and hypothesis regarding interactions of vitamin A, retinoids and hepatitis B virus infection).
Van Zander J, Orlow SJ. (2005). Efficacy and safety of oral retinoids in psoriasis. Expert Opin Drug Saf. (Review of acitretin and other retinoids as therapy of psoriasis; side effects include ALT elevations in one third of treated patients, but clinically apparent liver injury is rare).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, one was attributed to acitretin: Case 1 for acitretin).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, isotretinoin was the most frequently mentioned agent [420 cases: 6.4%], but no information on the characteristics of the cases is provided).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to vitamin A or a retinoid).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, two of which were attributed to retinoids).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and Outcomes of 899 Patients With Drug-Induced Liver Injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 3 cases were attributed to acitretin, but none to other retinoids or vitamin A).
DeKlotz CMC, Roby KD, Friedlander SF. (2017). Dietary supplements, isotretinoin, and liver toxicity in adolescents: a retrospective case series. Pediatrics. (Eight adolescents with acne in an isotretinoin monitoring program were found to have mild elevations in serum aminotransferase levels [ALT 34-59 U/L, AST 41-187 U/L, bilirubin normal and Alk P not provided], but all were also taking herbal and dietary supplements, including green tea, energy shakes and amino acids and creatine, and the elevations appeared to be more related to these products than the isotretinoin therapy).
(2019). Drugs for psoriasis. Med Lett Drugs Ther. (Concise review of the drugs approved for use in psoriasis including their mechanism of action, clinical efficacy, safety and costs, mentions that acitretin has significant mucocutaneous toxicity with cheilitis, hair loss, dry skin and desquamation and that about one third of patients have ALT elevations during therapy that are usually mild and transient but can evolve into clinically significant liver injury and can lead to cirrhosis).
Barbieri JS, Frieden IJ, Nagler AR. (2020). Isotretinoin, patient safety, and patient-centered care-time to reform iPLEDGE. JAMA Dermatol. (Viewpoint on the FDA program restricting use of isotretinoin and requiring rigorous monitoring for birth control, mentions that pregnancy prevention programs are often ineffective but can be financially burdensome and interfere with appropriate therapy of severe acne; no discussion of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Retinoids: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Retinoids/AE+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Retinoids: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Retinoids)